# Ezogabine

## OVERVIEW

### Introduction

Ezogabine, which is known as retigabine in Europe, is a unique anticonvulsant used largely as an adjunctive agent in the treatment of partial seizures. Therapy with ezogabine has not been associated with serum aminotransferase elevations, and clinically apparent liver injury from ezogabine has yet to be reported and must be rare, if it occurs at all.

### Background

Ezogabine (e zog' a been) is an anticonvulsant with a unique mechanism of action, decreasing excitability and seizure activity by opening voltage-gated potassium channels in the brain. Ezogabine has been shown to be effective both as monotherapy and in combination with other anticonvulsants for partial seizures. Ezogabine was approved for use in the United States in 2011 and current indications are as adjunctive therapy for partial seizures. Ezogabine is available in tablets of 50, 200, 300 and 400 mg under the brand name Potiga in the United States and Trobalt in Europe and elsewhere. The recommended initial dose in adults is 100 mg three times daily, which can be increased to 200 to 400 mg three times daily. The dose should be increased and tapered gradually. The most common side effects are dose related and include dizziness, somnolence, impaired concentration, nervousness, headache, fatigue nausea, weakness and tremor. Long term therapy has been associated with urinary retention and blue discoloration of the skin, lips, sclera and retina. Rare, but potentially severe adverse events include psychiatric symptoms such as confusion and hallucination and decrease in visual acuity as a result of retinal pigmentation.

### Hepatotoxicity

Limited data are available on the hepatotoxicity of ezogabine. In clinical trials, therapy with ezogabine was not associated with an increased frequency of serum aminotransferase elevations as compared to placebo treatment, and there were no instances of clinically apparent liver injury. No individual case reports of ezogabine hepatotoxicity have been published since its more wide spread clinical availability. Thus, clinically apparent liver injury due to ezogabine must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Ezogabine is extensively metabolized by the liver, largely by glucuronidation and acetylation. However, its metabolism is independent of microsomal P450 system and it has no effect on P450 activity and lacks significant drug-drug interactions.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ezogabine – Potiga®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ezogabine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ezogabine | 150812-12-7 | C16-H18-F-N3-O2 | Chemical Structure for Ezogabine

## ANNOTATED BIBLIOGRAPHY

References updated: 18 February 2018

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; ezogabine is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; ezogabine is not discussed).
McNamara JO. Pharmacology of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman.s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 583-607. (Textbook of pharmacology and therapeutics).
Porter RJ, Partiot A, Sachdeo R, Nohria V, Alves WM; 205 Study Group. Randomized, multicenter, dose-ranging trial of retigabine for partial-onset seizures. Neurology 2007; 68: 1197-204. (Among 309 patients with partial seizures treated for 16 weeks with one of 3 doses of ezogabine or placebo, side effects were largely CNS related and "there were no clinically relevant findings related to ... clinical laboratory measurements"). 17420403
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, valproate accounted for 6 cases, lamotrigine 5, phenytoin 5, gabapentin and topiramate 1 each; none were due to ezogabine). 18955056
Brodie MJ, Lerche H, Gil-Nagel A, Elger C, Hall S, Shin P, Nohria V, et al.; RESTORE 2 Study Group. Efficacy and safety of adjunctive ezogabine(retigabine) in refractory partial epilepsy. Neurology 2010; 75: 1817-24. (Among 538 patients with partial seizures treated with two doses of ezogabine or placebo, adverse events were mild-to-moderate in severity, possibly dose related and largely CNS related; ALT elevations above 3 times ULN occurred in 2.5% of ezogabine vs 3.9% of placebo recipients). 20944074
French JA, Abou-Khalil BW, Leroy RF, Yacubian EM, Shin P, Hall S, Mansbach H, et al; RESTORE 1/Study 301 Investigators. Randomized, double-blind, placebo-controlled trial of ezogabine (retigabine) in partial epilepsy. Neurology 2011; 76: 1555-63. (Among 305 patients with partial seizures treated with ezogabine or placebo for 18 weeks, there were "...no clinically significant abnormal results or trends in laboratory values"). 21451152
Knowles SR, Dewhurst N, Shear NH. Anticonvulsant hypersensitivity syndrome: an update. Expert Opin Drug Saf 2012; 11: 767-78. (Updated review of anticonvulsant hypersensitivity syndrome which is associated with phenytoin, phenobarbital, lamotrigine and carbamazepine, and rarely with zonisamide, valproate and oxcarbazepine; ezogabine is not mentioned). 22794330
Yamada M, Welty TE. Ezogabine: an evaluation of its efficacy and safety as adjunctive therapy for partial-onset seizures in adults. Ann Pharmacother 2012; 46: 1358-67. (Systematic review of efficacy and safety of ezogabine states that in 3 large clinical trials side effects were generally mild-to-moderate [dizziness, somnolence, confusion, fatigue, headache and dysarthria]; no mention of ALT elevations or hepatotoxicity). 22991134
Gil-Nagel A, Brodie MJ, Leroy R, Cyr T, Hall S, Castiglia M, Twomey C, VanLandingham K. Safety and efficacy of ezogabine (retigabine) in adults with refractory partial-onset seizures: Interim results from two ongoing open-label studies. Epilepsy Res 2012; 102 (1-2): 117-21. (Among 336 patients with partial seizures treated with ezogabine in 2 open label studies, 3% had urinary retention; no mention of ALT elevations or hepatotoxicity). 22771137
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants; tiagabine is approved only for treatment of partial seizures and has prominent gastrointestinal and CNS side effects; no mention of hepatotoxicity). 23348233
Faulkner MA, Burke RA. Safety profile of two novel antiepileptic agents approved for the treatment of refractory partial seizures: ezogabine (retigabine) and perampanel. Expert Opin Drug Saf 2013; 12: 847-55. (Review of safety of ezogabine from 3 phase III studies states that "no negative laboratory, ECG or vital sign events were documented"). 23883095
Biton V, Gil-Nagel A, Brodie MJ, Derossett SE, Nohria V. Safety and tolerability of different titration rates of retigabine (ezogabine) in patients with partial-onset seizures. Epilepsy Res 2013; 107: 138-45. (Among 77 patients with partial onset seizures treated with ezogabine for up to 50 days, "...changes from baseline in clinical laboratory parameters ...were not clinically relevant"). 24094693
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none specifically to ezogabine). 25754159
Lerche H, Daniluk J, Lotay N, DeRossett S, Edwards S, Brandt C. Efficacy and safety of ezogabine/retigabine as adjunctive therapy to specified single antiepileptic medications in an open-label study of adults with partial-onset seizures. Seizure 2015; 30: 93-100. (Among 203 patients with partial onset seizures and inadequate control on a single anticonvulsant who added ezogabine using flexible doses, the response rate was 54% while common adverse events were dizziness [26%], somnolence [21%] and fatigue [8%], but there were "no clinically significant changes in hematology or clinical chemistry data from baseline"). 26216692
Clark S, Antell A, Kaufman K. New antiepileptic medication linked to blue discoloration of the skin and eyes. Ther Adv Drug Saf 2015; 6: 15-9. (Review of problematic adverse events of ezogabine which have led to an FDA alert including urinary retention [probably due to its effects on potassium channels in the bladder], prolongation of QTc interval, psychiatric symptoms such as confusion, euphoria, and hallucinations, and blue-gray discoloration of skin, lips, nails, sclera and retina which cause decrease in visual acuity especially with prolonged use; no mention of ALT elevations or hepatotoxicity). 25642319
Lim KS, Lotay N, White R, Kwan P. Efficacy and safety of retigabine/ezogabine as adjunctive therapy in adult Asian patients with drug-resistant partial-onset seizures: A randomized, placebo-controlled Phase III study. Epilepsy Behav 2016; 61: 224-30. (Among 75 Asian adults with partial onset seizures treated with ezogabine [600 or 900 mg] or placebo once daily for 16 weeks, response rates were 31% and 17% with ezogabine vs 0% with placebo and there were "no safety concerns" and no mention of ALT elevations or hepatotoxicity). 27376872
Zaccara G, Giovannelli F, Giorgi FS, Franco V, Gasparini S, Benedetto U. Tolerability of new antiepileptic drugs: a network meta-analysis. Eur J Clin Pharmacol 2017; 73: 811-7. (Metaanalysis of the comparative tolerability of 18 new anticonvulsant agents including tiagabine but not ezogabine, found lowest rates of withdrawal for adverse events with levetiracetam, brivaracetam, and gabapentin with lowest tolerability from eslicarbazepine, oxcarbazepine, lacosamide and topiramate; tiagabine had an intermediate level of tolerability). 28378057
Drugs for epilepsy. Med Lett Drugs Ther 2017; 59 (1526): 121-30. (Concise review of the drugs available for therapy of epilepsy does not list ezogabine as either a first or second line drug for epilepsy and does not discuss it as a specific agent). 28746301

## OTHER REFERENCE LINKS

1. Recent References on Ezogabine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ezogabine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ezogabine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ezogabine)